# Echinocandins

## OVERVIEW

### Introduction

The echinocandins include anidulafungin, caspofungin, and micafungin and are a relatively new class of antifungal agents that are administered parenterally and are used in therapy or prevention of serious, invasive aspergillosis and candidal infections. All three agents can cause transient and asymptomatic serum aminotransferase elevations, and individual instances of acute liver injury have been observed during therapy with these agents, but none has been definitely shown to cause clinically apparent acute drug induced liver injury.

### Background

The echinocandins are a relatively new class of antifungal agents, whose activity is due to inhibition of glucan synthetase, the enzyme that is responsible for synthesis of β-1, 3-D-glucan, an essential component of the cell wall of filamentous fungi, such as Aspergillus and Candida species. This enzyme inhibition results in alteration in the fungal membrane integrity, followed by cell ballooning and, for Candida cells, lysis. Three echinocandins are available for use: caspofungin (kas" poe fun' jin), micafungin (mye" ka fun' jin) and anidulafungin (ay nid" ue la fun' jin). Caspofungin was approved for use in the United States in 2001, micafungin in 2005 and anidulafungin in 2006. All three are given intravenously and currently approved for therapy of esophageal candidiasis and for severe, disseminated or invasive candidiasis. Caspofungin is also approved for use as a secondary therapy of invasive aspergillosis and as empirical therapy for presumed fungal infection in febrile, neutropenic patients. Micafungin is also approved for prophylaxis against candidiasis in hematopoietic stem cell transplant recipients. Caspofungin is available under the brand name Cancidas in a formulation for intravenous use, the recommended dose in adults being 70 mg on the first day of treatment followed by 50 or 100 mg daily. Micafungin is available under the brand name of Mycamine in an intravenous formation, the recommended dosage being 50 mg daily for prophylaxis and 100 to 150 mg daily for therapy of candidemia. Anidulafungin is available under the brand name of Eraxis in intravenous formulations and the recommended dosage for disseminated candidal infection is 200 mg on day 1 followed by 100 mg daily. The echinocandins are administered intravenously in a slow infusion over one hour (to decrease the risk of acute infusion reactions). Common side effects include phlebitis and the histamine-like reaction marked by rash, urticaria, flushing, bronchospam, hypotension and facial swelling.

### Hepatotoxicity

Transient elevations in liver enzymes have occurred in 2% to 15% of patients treated with the echinocandins, typically returning to baseline after withdrawal of therapy. Clinically apparent hepatotoxicity has occurred in isolated cases; however, a causal relationship to the antifungal agent is often difficult to prove, as these agents are typically used in persons who are critically ill and have other conditions that are associated with liver injury. The largest experience has been with caspofungin, which may have a higher rate of serum enzyme elevations than with micafungin or anidulafungin and has more frequently been linked to cases of acute, symptomatic liver injury. Nevertheless, the product label for all three echinocandins mentions adverse events of serum enzyme elevations, hepatitis and acute liver failure.

Likelihood score: D (possible cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of serum aminotransferase elevations during echinocandin therapy is unknown. In preclinical studies in animals, highest drug concentrations are found in the liver and a direct toxic effect or production of a toxic intermediate may be the cause of the abnormalities.

### Outcome and Management

The liver injury seen with caspofungin, micafungin and anidulafungin rarely progresses beyond mild serum enzyme elevations. Caution should be taken in patients with preexisting hepatic insufficiency in whom the likelihood of severe acute liver injury appears to be greatest. Product labels for the echinocandins recommend monitoring of liver tests during therapy, particularly in patients with underlying liver disease. The effects of rechallenge and cross reactivity to hepatic injury among the echinocandins has not been evaluated.

Drug Class: Antifungal Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Anidulafungin – Eraxis®

Caspofungin – Cancidas®

Micafungin – Mycamine®

DRUG CLASS

Antifungal Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=echinocandins)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Anidulafungin | 166663-25-8 | C58-H73-N7-O17 | Anidulafungin chemical structure
Caspofungin | 162808-62-0 | C52-H88-N10-O15 | Caspofungin chemical structure
Micafungin | 235114-32-6 | C56-H71-N9-O23-S | Micafungin chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 05 July 2017

Zimmerman HJ. Antifungal agents. Hhepatic injury from antimicrobial agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 609-11. (Expert review of hepatotoxicity of antifungal agents published in 1999 before availability of the echinocandins).
Moseley RH. Antifungal agents. Hepatotoxicity of antimicrobials and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 470-3. (Review of hepatotoxicity of antifungal agents; caspofungin was the first of a new class of parenterally administered antifungal agents; mentions that elevations in ALT levels occur in 2-4% of patients during caspofungin therapy and that adverse reactions are less frequent with micafungin and anidulafungin).
Bennett JE. Antifungal agents. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1571-93. (Textbook of pharmacology and therapeutics; the echinocandins have activity against fungal organisms acting to inhibit glucan synthesis; the 3 agents in clinical use have similar mechanism of action, but different pharmalogical properties).
Mora-Duarte J, Betts R, Rotstein C, Colombo AL, Thompson-Moya L, Smietana J, Lupinacci R, et al.; Caspofungin Invasive Candidiasis Study Group. Comparison of caspofungin and amphotericin B for invasive candidiasis. N Engl J Med 2002; 347: 2020-9. (Controlled trial comparing caspofungin and amphotericin B in 224 adults with invasive candidiasis; similar efficacy but lower rate of side effects with caspofungin vs amphotericin: elevated ALT levels in 3.7% vs 8.1%, Alk P 8.3% vs 15.6%, bilirubin 2.8% vs 8.9%, but no serious hepatic adverse events attributed to either). 12490683
Villanueva A, Gotuzzo E, Arathoon EG, Noriega LM, Kartsonis NA, Lupinacci RJ, Smietana JM, et al. A randomized double-blind study of caspofungin versus fluconazole for the treatment of esophageal candidiasis. Am J Med 2002; 113: 294-9. (Among 177 patients with esophageal candidiasis treated with either caspofungin or fluconazole for 14-42 days, serum ALT and Alk P elevations were more frequent with fluconazole [12% and 12%] than anidulafungin [5% and 9%], but no patient developed clinically apparent liver injury). 12361815
Marr KA, Hachem R, Papanicolaou G, Somani J, Arduino JM, Lipka CJ, Ngai AL, et al. Retrospective study of the hepatic safety profile of patients concomitantly treated with caspofungin and cyclosporin A. Transpl Infect Dis 2004; 6: 110-6. (Retrospective study of 40 patients who received both caspofungin and cyclosporin A from 4 medical centers; 24 [60%] had at least one serum enzyme elevation and 4 [10%] stopped therapy because of hepatotoxicity; nevertheless, it was difficult to attribute the hepatic injury to caspofungin and “no severe hepatic adverse events were noted”). 15569226
Maertens J, Raad I, Petrikkos G, Boogaerts M, Selleslag D, Petersen FB, Sable CA, et al.; Caspofungin Salvage Aspergillosis Study Group. Efficacy and safety of Caspofungin for treatment of invasive aspergillosis in patients refractory to or intolerant of conventional antifungal therapy. Clin Infect Dis 2004; 39: 1563-71. (Experience in treating 83 patients with invasive aspergillosis with caspofungin for an average of 28 days; ALT elevations occurred in only one patient and no serious drug related hepatic adverse events were reported). 15578352
Wagner C, Graninger W, Presterl E, Joukhadar C. The echinocandins: comparison of their pharmacokinetics, pharmacodynamics and clinical applications. Pharmacology 2006; 78: 161-77. (Review of structure, pharmacology, clinical efficacy and safety of the echinocandins; elevations in ALT levels occur in up to 10% of patients treated with caspofungin, may be less with micafungin and anidulafungin). 7047411
Bennett JE. Echinocandins for candidemia in adults without neutropenia. N Engl J Med 2006; 355: 1154-9. (Concise review on use of echinocandins in invasive fungal infections; ALT elevations occur in 11% of patients receiving caspofungin; isolated cases of clinically significant hepatic injury have occurred, “although it is not clear whether they were drug-related.”). 16971721
Reboli AC, Rotstein C, Pappas PG, Chapman SW, Kett DH, Kumar D, Betts R, et al.; Anidulafungin Study Group. Anidulafungin versus fluconazole for invasive candidiasis. N Engl J Med 2007; 356: 2472-82. (Among 245 patients with invasive candidiasis treated with either caspofungin or fluconazole for 14-42 days, serum enzyme elevations were more frequent with fluconazole [7%] than anidulafungin [1.5%]). 17568028
Cappelletty D, Eiselstein-McKitrick K. The echinocandins. Pharmacotherapy 2007; 27: 369-88. (Review of structure, pharmacokinetics, activity, clinical efficacy and side effects of the echinocandins; ALT elevations occur in 1-15% with caspofungin, 1-8% with micafungin, and 3-5% with anidulafungin). 17316149
Anttila VJ, Salonen J, Ylipalosaari P, Koivula I, Riikonen P, Nikoskelainen J. A retrospective nationwide case study on the use of a new antifungal agent: patients treated with caspofungin during 2001-2004 in Finland. Clin Microbiol Infect 2007; 13: 606-12. (Retrospective analysis of 78 patients treated with caspofungin in Finland; 2 had severe hepatic toxicity, but the role of medication was uncertain as other factors were present, one patient died of acute liver failure after stopping caspofungin). 17378926
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 8 were attributed to antifungal agents, including 4 to terbinafine, 2 to fluconazole, 1 each to ketaconazole and itraconazole but none to the echinocandins). 18955056
Fortún J, Martín-Dávila P, Montejo M, Muñoz P, Cisneros JM, Ramos A, Aragón C, et al.; GESITRA Study Group. Prophylaxis with caspofungin for invasive fungal infections in high-risk liver transplant recipients. Transplantation 2009; 87: 424-35. (Experience in using caspofungin for 21-90 days as prophylaxis against invasive fungal infections in 71 high risk liver transplant recipients; ALT elevations were frequent, but difficult to relate to drug because of the underlying condition). 19202450
Zaoutis TE, Jafri HS, Huang LM, Locatelli F, Barzilai A, Ebell W, Steinbach WJ, et al. A prospective, multicenter study of caspofungin for the treatment of documented Candida or Aspergillus infections in pediatric patients. Pediatrics 2009; 123: 877-84. (Open label study of caspofungin for 2 to 87 days in 49 children with invasive fungal infections; ALT elevations occurred in 14.6%, all resolved despite continuation of therapy and none were clinically apparent). 19255017
Antifungal drugs. Treat Guidel Med Lett 2009; 7: 95-102. (Concise summary of therapy of fungal infections with recommendations on agents, dosage and duration of treatment and safety; mentions that the echinocandins all have mild hepatic toxicities). 19940816
Menichetti F. Anidulafungin, a new echinocandin: effectiveness and tolerability. Drugs 2009; 69 Suppl 1: 95-7. (Review of efficacy and safety of anidulafungin mentions that adverse events are uncommon, but include increases in GGT, ALT and AST levels). 19877741
King KY, Edwards MS, Word BM. Hepatitis associated with micafungin use in a preterm infant. J Perinatol 2009; 29: 320-2. (Female premature newborn [HCV- and HIV-exposed] developed elevation in liver tests starting on day 2 of micafungin therapy, with peak on day 16 [bilirubin 16.3 mg/dL, ALT 860 U/L], liver tests improved gradually following discontinuation of drug). 19325554
Wang JL, Chang CH, Young-Xu Y, Chan KA. Systematic review and meta-analysis of the tolerability and hepatotoxicity of antifungals in empirical and definitive therapy for invasive fungal infection. Antimicrob Agents Chemother 2010; 54: 2409-19. (Systematic review of 39 controlled trials in more than 8000 patients, found liver enzyme elevations in 14.5% of patients on amphotericin (pooled estimate); 19.7% on voriconazole; 18.9% itraconazole; 10% fluconazole; 2.8% anidulafungin; 7.2% caspofungin; and 5.7% micafungin). 20308378
Arrieta AC, Maddison P, Groll AH. Safety of micafungin in pediatric clinical trials. Pediatr Infect Dis J 2011; 30: e97-e102. (Review of 6 clinical trials of micafungin in pediatric patients found 3% of 296 children developed “treatment related” ALT elevations, but no mention was made of clinically apparent liver injury). 21378595
Cornely OA, Pappas PG, Young JA, Maddison P, Ullmann AJ. Accumulated safety data of micafungin in therapy and prophylaxis in fungal diseases. Expert Opin Drug Saf 2011; 10: 171-83. (Review of pooled adverse event data from 17 clinical studies of micafungin in 3028 patients found 8.6% had treatment related hepatic adverse events, 2% had ALT elevations, 1% hyperbilirubinemia, 0.5% required treatment discontinuation, and 0.1% had hepatic failure, but no specifics given). 21306282
Valerio M, Muñoz P, Bouza E. [Liver toxicity of micafungin. Is this drug safe?]. Enferm Infecc Microbiol Clin 2011; 29 Suppl 2: 29-32. Spanish. (Review of safety of micafungin, mentions that ALT elevations occur in 7% of patients treated with caspofungin, 3% with micafungin and 2% with anidulafungin). 21420574
Doria C, Bodzin AS, Vaccino S, Daskalakis C, Krawitz S, Ramirez CB. A retrospective analysis of the use of caspofungin in recipients of liver transplant with a modified high index of suspicion for fungal infection. A critical review of mortality, acute cellular rejection, infections, and changes in the liver function tests while on caspofungin. Clin Transplant 2011; 25: 569-75. (Among 82 liver transplant recipients, 16 received caspofungin in the early posttransplant period for suspected invasive fungal infection, 3 [13%] of whom had transient rise in ALT or AST, but none of whom required dose modification). 20662881
Yamaguchi M, Kurokawa T, Ishiyama K, Aoki G, Ueda M, Matano S, Takami A, et al. Efficacy and safety of micafungin as an empirical therapy for invasive fungal infections in patients with hematologic disorders: a multicenter, prospective study. Ann Hematol 2011; 90: 1209-17. (Among 121 adults with hematologic disorders treated with micafungin for either febrile neutropenia or suspected invasive fungal infection, 4 [3.3%] developed ALT elevations and one developed jaunidice). 21695388
Goto N, Hara T, Tsurumi H, Ogawa K, Kitagawa J, Kanemura N, Kasahara S, et al. Efficacy and safety of micafungin for treating febrile neutropenia in hematological malignancies. Am J Hematol 2010; 85: 872-6. (Among 53 patients with febrile neutropenia treated with micafungin, 6 developed AST elevations, but all were transient, mild [<3 times ULN], and asymptomatic). 20882524
Wang LL, Zhuge X, Xiao GH, Zhang Y. Hepatic safety of caspofungin during treatment of invasive fungal diseases in elderly patients. Chin Med J (Engl) 2012; 125: 2240. (Among 50 patients above 80 years of age treated with caspofungin for invasive fungal disease, 21 had abnormal liver tests before treatment, of whom 3 [14%] worsened on therapy [1 mild and 2 severe] compared to 2 of 29 with normal liver tests initially, of whom 2 worsened [7%], but both were mild). 22884162
León-Gil C, Ubeda-Iglesias A, Loza-Vázquez A, de la Torre MV, Raurich-Puigdevall JM, Alvarez-Sánchez B, Ortiz-Leyva C, et al; ProCAS Study Group. Efficacy and safety of caspofungin in critically ill patients. ProCAS Study. Rev Esp Quimioter 2012; 25: 274-82. (Among 98 critically ill patients with severe fungal infections treated with caspofungin for 9-21 days, there were no significant changes in serum bilirubin, ALT or Alk P levels and no liver related serious adverse events). 23303260
Ruhnke M, Paiva JA, Meersseman W, Pachl J, Grigoras I, Sganga G, Menichetti F, et al. Anidulafungin for the treatment of candidaemia/invasive candidiasis in selected critically ill patients. Clin Microbiol Infect 2012; 18: 680-7. (Among 216 critically ill patients with invasive fungal infections treated with anidulafungin for 10 to 42 days, 3 [1.7%] developed AST elevations above 5 times ULN, but there were no liver related serious adverse events). 22404732
Kohno S, Izumikawa K, Yoshida M, Takesue Y, Oka S, Kamei K, Miyazaki Y, et al. A double-blind comparative study of the safetyand efficacy of caspofungin versus micafungin in the treatment of candidiasis andaspergillosis. Eur J Clin Microbiol Infect Dis 2013; 32: 387-97. (Among 121 patients with invasive fungal infections randomized to receive either micafungin or caspofungin, ALT elevations occurred in 8.3% of caspofungin vs 6.7% of micafungin treated patients and were above 5 times ULN in 0% vs 3%, but no patient developed clinically apparent liver injury with jaundice). 23052987
Kobayashi R, Suzuki N, Yoshida M, Iizuka S, Suzuki D, Sano H, Kudoh T. Efficacy and safety of micafungin for febrile neutropenia in pediatric patients with hematological malignancies: a multicenter prospective study. J Pediatr Hematol Oncol 2013; 35: e276-9. (Among 25 children with 30 episodes of febrile neutopenia after cancer chemotherapy who were treated with micafungin for 6 to 47 days, ALT elevations occurred in 2, but were transient and mild, not requiring dose modification). 23743960
Yamazaki S, Nakamura F, Yoshimi A, Ichikawa M, Nannya Y, Kurokawa M. Safety of high-dose micafungin for patients with hematological diseases. Leuk Lymphoma 2014 Mar 7. [Epub ahead of print] (Retrospective analysis of safety of two doses of micafungin for invasive fungal infections, found any elevation in ALT in 26% of 58 recipients of standard dose [150 mg/day: n=58] vs 27% of 26 recipients of high dose [300 mg/day], and elevations above 5 times ULN in only 1 patient in each group). 24460099
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to an echinocandin). 25754159
Jung DS, Tverdek FP, Jiang Y, Kontoyiannis DP. Switching to anidulafungin from caspofungin in cancer patients in the setting of liver dysfunction is associated with improvement of liver function tests. J Antimicrob Chemother 2015; 70: 3100-6. (In a retrospective study of 61 patients who developed abnormal liver tests during treatment with caspofungin and were then switched to anidulafungin, values improved overall, mean ALT falling from 132 to 71 U/L and bilirubin from 2.5 to 2.2 mg/dL, suggesting that anidulafungin is less hepatotoxic than caspofungin). 26311837
Kyriakidis I, Tragiannidis A, Munchen S, Groll AH. Clinical hepatotoxicity associated with antifungal agents. Expert Opin Drug Saf 2017; 16: 149-65. (Review of the hepatotoxicity of antifungal agents discusses the frequency of serum enzyme elevations during anidulafungin, caspofungin and micafungin therapy but not clinically apparent liver injury). 27927037

## OTHER REFERENCE LINKS

1. Recent References on Echinocandins: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(echinocandins)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222010/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Echinocandins: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=echinocandins)